# Hoodia

## OVERVIEW

### Introduction

Hoodia is succulent, cactus-like plant of the Kalahari Desert, extracts of which are marketed as weight loss aids. Hoodia has not been implicated in causing serum enzyme elevations or clinically apparent liver injury.

### Background

Hoodia is prepared from the stems and roots of the succlent plant Hoodia gordonii found in the Kalahari Desert and claimed to be used traditionally by Kalahari Bushmen to reduce their hunger and thirst during long hunts. However, it may be more accurate to say that Hoodia is a food source and was used mostly to quench thirst. Nevertheless, scientific studies in laboratory animals have shown that extracts of hoodia containing an oxypregnane steroidal glycoside have appetite suppressing activity. The traditional use and subsequent laboratory findings led to the marketing of hoodia as a weight loss agent. Dried extracts of stems and roots are used to make powders, capsules, chewable tablets and liquid preparations for making teas. Hoodia is often combined with other purported weight loss herbs such as green tea and chromium picolinate. To date, there have been no prospective controlled trials demonstrating an effect of hoodia on food intake or weight management in humans. In uncontrolled studies, use of hoodia has been reported to have no adverse side effects.

### Hepatotoxicity

Hoodia has been in use as a weight loss agent for several years and has not been convincingly linked to instances of acute liver injury. In a small controlled trial, serum alkaline phosphatase [8-17 U/L] and bilirubin [0.2-0.6 mg/dL], but not ALT levels, were slightly higher in patients on Hoodia compared to placebo, but no patient developed symptoms or clinically apparent liver injury.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Other Names: Kalahari cactus, Xhoba

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Hoodia – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://nccih.nih.gov/health/hoodia)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Hoodia | ID: H710000000 | Herbal mixture | Not applicable

## ANNOTATED BIBLIOGRAPHY

References updated: 28 March 2018

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; hoodia is not discussed).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; hoodia is not discussed).
Hoodia. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 453-7. (Compilation of short monographs on herbal medications and dietary supplements).
van Heerden FR, Marthinus Horak R, Maharaj VJ, Vleggaar R, Senabe JV, Gunning PJ. An appetite suppressant from Hoodia species. Phytochemistry 2007; 68: 2545-53. (Extracts of Hoodia gordonii have appetite suppressant activity in a rat model, found largely in fractions with pregnane glycosides). 17603088
Avula B, Wang YH, Pawar RS, Shukla YJ, Smillie TJ, Khan IA. A rapid method for chemical fingerprint analysis of Hoodia species, related genera, and dietary supplements using UPLC-UV-MS. J Pharm Biomed Anal 2008; 48: 722-31. (The demand for Hoodia gordonii has resulted in use of other species which may not have appetite suppressant activity; using chromatography and mass spectrometry, it is possible to identify the fingerprint of the 12 hoodigosides and correctly identify products from H. gordonii). 18718731
van Heerden FR. Hoodia gordonii: a natural appetite suppressant. J Ethnopharmacol 2008; 119: 434-7. (Hoodia is a multistemmed succulent which is classified as a stapeliad [and not related to the cactus family], which is found in South Africa and was used by native people as food and to quench thirst, but has been marketed and become popular as an appetite suppressant, the clinical bases for the claims being weak; hoodia contains multiple pregnane glycosides which are being evaluated for appetite suppressant activity). 18804523
Whelan AM, Jurgens TM, Szeto V. Case report. Efficacy of Hoodia for weight loss: is there evidence to support the efficacy claims? J Clin Pharm Ther 2010; 35: 609-12 (Review of literature on hoodia found no prospective control trials of its efficacy; open label studies reported that its appetite suppressing activity was promising and that it had no adverse events). 20831685
Blom WA, Abrahamse SL, Bradford R, Duchateau GS, Theis W, Orsi A, Ward CL, Mela DJ. Effects of 15-d repeated consumption of Hoodia gordonii purified extract on safety, ad libitum energy intake, and body weight in healthy, overweight women: a randomized controlled trial. Am J Clin Nutr 2011; 94: 1171-81. (In a controlled trial of 15 days of hoodia vs placebo in 49 overweight women, hoodia was associated with abnormal skin sensitivity, nausea, vomiting, increases in blood pressure and elevations in total [indirect] bilirubin and Alk P without a change in ALT levels, clinically apparent liver injury or decrease in caloric intake). 21993434
Bunchorntavakul C, Reddy KR. Review article: herbal and dietary supplement hepatotoxicity. Aliment Pharmacol Ther 2013; 37: 3-17. (Review of HDS associated hepatotoxicity; does not mention hoodia). 23121117
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, including 15 [16%] due to herbal and dietary supplements, but none listed hoodia as an ingredient). 23419359
Smith C, Krygsman A. Hoodia gordonii: to eat, or not to eat. J Ethnopharmacol 2014; 155: 987-91. (Review of the physiologic effects of Hoodia gordonii, which has been marketed as a weight loss aid, concludes that its effects on energy intake are not well documented, particularly in humans, and that the doses needed for an effect have adverse events that are concerning; no mention of ALT elevations or liver-related side effects). 24955559
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60:1399-408. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed to hoodia). 25043597
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], none of which were primarily attributed to hoodia: see Navarro [2014]). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Hoodia: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Hoodia/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Hoodia: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Hoodia)